# Acitretin

## OVERVIEW

### Introduction

Acitretin is a retinoid and vitamin A derivative currently used in the treatment of psoriasis. Acitretin, like many retinoids, can lead to increase in serum aminotransferase levels and has been implicated in cases of acute liver injury which can be severe and even fatal.

### Background

Acitretin (a" si tre' tin) is an aromatic retinoid and the major metabolite of etretinate (e tret' i nate). Acitretin has replaced etretinate in clinical practice in the therapy of psoriasis because of its more favorable pharmacokinetics and half-life. Its mechanism of action in psoriasis is believed to be mediated by activation of retinoic acid and retinoid X receptors, which regulate gene expression important in growth and differentiation. Acitretin is considered a second generation retinoid and its relative lack of receptor specificity accounts for its many adverse side effects. All oral retinoids are potent teratogens and must be avoided or used with extreme caution in women of childbearing potential. Acitretin was approved for use in psoriasis and acne in the United States in 1996, but is currently used only in therapy of severe psoriasis unresponsive to conventional therapies and under strict regulations regarding monitoring and birth control. Acitretin is available generically and under the brand name of Soriatane in capsules of 10, 17.5, 22.5 and 25 mg, the usual dose in adults being 25 to 50 mg per day. Common side effects include dry skin, nose bleeds, conjunctivitis and hair loss. Acitretin is a known teratogen and embryotoxin. Use of acitretin has also been linked to worsening of hyperlipidemia, hyperostosis, vision and hearing loss, pancreatitis, pseudotumor cerebri, birth defects, depression and suicide.

### Hepatotoxicity

Liver test abnormalities occur in up to one third of patients on acitretin, although marked elevations above three times the upper limit of normal occur in only 1% to 5%. These abnormalities are typically transient, not accompanied by symptoms and can resolve even with continuation of acitretin, but they may be associated with mild symptoms and require drug discontinuation in up to 4% of patients.

Acitretin can also cause clinically apparent liver injury with symptoms and jaundice. Although uncommon, acute liver injury from acitretin is well described and is estimated to occur in 0.1% to 0.5% of treated patients. The onset of injury can be as soon as one week or up to 9 months after starting therapy. The pattern of liver enzyme elevations is typically hepatocellular (Case 1), but cholestatic hepatitis due to acitretin has been reported (Case 2). Most cases resolve rapidly with stopping acitretin. Rash, fever, eosinophilia and other signs of hypersensitivity occur in many but not all cases; autoantibodies are rare. The injury is not at all like that of vitamin A and is not associated with fat accumulation in stellate cells. Because its potential for causing hepatotoxicity, routine monitoring of serum aminotransferase levels during acitretin therapy is recommended.

Likelihood score, acitretin: B (likely rare cause of clinically apparent liver injury).

A similar pattern of acute liver injury was reported with etretinate, a related retinoid that was previously used for psoriasis and acne, but was withdrawn from use in the United States in 1998.

Likelihood score, etretinate: B (highly likely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which acitretin causes serum aminotransferase elevation is not known. The injury does not resemble that of hypervitaminosis A and excess acitretin is not stored in the liver or in stellate cells as is vitamin A. The rare clinically apparent cases of hepatotoxicity are likely due to hypersensitivity.

### Outcome and Management

The serum aminotransferase elevations that occur on acitretin therapy are usually self-limited and may not require dose modification or discontinuation of therapy. However, persistent ALT or AST elevations above 3 times the upper limit of the normal range (ULN) should lead to dose adjustment or discontinuation. Any ALT elevation above 10 times the ULN or ALT elevations with symptoms or jaundice should lead to immediate discontinuation (Case 1). The acute clinically apparent liver injury caused by acitretin is typically self-limited and benign but fatal instances (particularly with overdose or use of high doses of acitretin) have been reported. Concurrent therapy with methotrexate may increase the risk of hepatotoxicity from acitretin. No instances of chronic hepatitis or vanishing bile duct syndrome due to acitretin have been reported. Restarting acitretin after clinically apparent liver injury is usually followed by recurrence and should be avoided.

Drug Class: Dermatologic Agents; Vitamins

Other Drugs in the Subclass:

- Vitamin A
- Retinoids
  - Isotretinoin
  - Bexarotene

## CASE REPORTS

### Case 1. Mild acute hepatitis due to acitretin.(1)

A 66 year old man was found to have elevations in serum aminotransferase levels during routine monitoring 9 months after starting acitretin (50 mg daily) for pityriasis rubra psoriaform. He had no symptoms of liver disease and felt well. Past medical history included rheumatoid arthritis for which he took acetaminophen intermittently and occasional courses of prednisone, the most recent course being a few weeks before recognition of the liver injury. He used hydroxyzine regularly for itching due to his skin disease. He did not drink alcohol and had no history of liver disease, exposures to jaundiced individuals or risk factors for viral hepatitis. Physical examination was unrevealing and he had no apparent jaundice, rash, fever or signs of chronic liver disease. Laboratory testing showed marked elevations in serum ALT (1015 U/L) and AST (893 U/L), with minimal increase in alkaline phosphatase (Alk P: 212 U/L) and mild hyperbilirubinemia (2.9 mg/dL). The serum albumin (3.9 g/dL) and prothrombin time (11.2 seconds) were normal. Serum creatinine was normal, and there was no eosinophilia. Tests for hepatitis A, B and C were negative. Serum ANA and AMA were strongly positive, but he was known to have serum autoantibodies previously. Hepatic imaging was not done. Acitretin was discontinued and laboratory results improved rapidly and were normal when he was seen 8 months later (Table).

#### Key Points

Medication: | Acitretin (50 mg daily)
Pattern: | Hepatocellular (R=13.2)
Severity: | 2+ (jaundice not requiring hospitalization)
Latency: | 9 months
Recovery: | 4 weeks
Other medications: | Hydroxyzine, acetaminophen

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Comments
1 month | 0 | 37 | 54 | 0.7 | Routine monitoring
5 months | 0 | 44 | 68 | 0.6
6 months | 0 | 20 | 68 | 0.5
7 months | 0 | 28 | 68 | 0.6
8 months | 0 | 56 | 82 | 0.6
9 months | 0 | 1015 | 212 | 2.9 | No symptoms
Acitretin discontinued because of abnormal liver tests
9.5 months | 2 weeks | 500 | 183 | 1.9
10 months | 4 weeks | 41 | 99 | 0.6
1.5 years | 9 months | 12 | 82 | 0.6
Normal Values | | <45 | <125 | <1.2

#### Comment

The laboratory abnormalities (hepatocellular pattern of serum enzyme elevations) and clinical course (prompt resolution with stopping therapy) were compatible with acitretin induced liver injury. These abnormalities were detected during routine screening for possible liver injury in an asymptomatic patient on acitretin. The height of the elevations (>10 times ULN) and the presence of hyperbilirubinemia called for immediate discontinuation of acitretin.

### Case 2. Severe acute hepatitis due to acitretin.(1)

A 58 year old man developed fatigue, anorexia, nausea and dark urine followed pruritus and jaundice 4 months after starting acitretin (50 mg daily) for psoriasis. Past medical history was otherwise unremarkable. He did not drink alcohol and had no history of liver disease or risk factors for viral hepatitis. He was also taking omeprazole which he had been taking for several years for gastroesophageal reflux. He had taken minocycline for several months but had discontinued it several weeks before becoming ill. Laboratory testing showed mild jaundice (bilirubin 4.4 mg/dL) and elevations in serum aminotransferase levels (ALT 600 U/L, AST 252 U/L) and alkaline phosphatase (Alk P: 256 U/L). The serum albumin (4.0 g/dL) and prothrombin time (INR 0.9) were normal. Acitretin was stopped promptly and he was admitted to the hospital for evaluation and monitoring (Table). Tests for hepatitis A, B, C and E were negative as were routine autoantibodies. Over the next 4 weeks his serum bilirubin continued to rise, peaking at 28.5 mg/dL. Itching was treated with cholestyramine and doxepin. Abdominal CT scans showed no evidence of biliary obstruction or hepatic masses. A liver biopsy showed severe cholestatic hepatitis suggestive of drug induced liver injury. Importantly, there was no bile duct injury or loss. He remained jaundiced for almost three months, but gradually improved and when seen in follow up 7 months after onset, he was asymptomatic and all liver tests were normal.

#### Key Points

Medication: | Acitretin (50 mg daily)
Pattern: | Hepatocellular (R=7.0) initially, cholestatic (R<1) later
Severity: | 3+ (jaundice, hospitalization)
Latency: | 5 months
Recovery: | 4 months
Other medications: | Omeprazole

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Comments
5 months | 0 | 600 | 256 | 4.4 | R=7.0, acitretin stopped
| 1 day | 310 | 145 | 5.2 | R=3.8, CT scan
| 6 days | 286 | 317 | 8.8
| 13 days | 111 | 395 | 14.1 | R=0.9
| 19 days | 62 | 425 | 20.2
6 months | 27 days | 59 | 438 | 24.3 | Severe pruritus
| 33 days | 62 | 488 | 27.3 | INR 1.0
| 35 days | 76 | 462 | 28.5 | Liver biopsy
| 41 days | 79 | 412 | 23.2
7 months | 62 days | 86 | 156 | 6.8
| 76 days | 75 | 138 | 3.6
8 months | 3 months | 46 | 109 | 1.3
1 year | 7 months | 42 | 85 | 1.2
Normal Values | | <45 | <125 | <1.2

#### Comment

This patient suffered a somewhat severe and protracted cholestatic hepatitis which arose 5 months after starting acitretin. Despite stopping the medication, he continued to have worsening jaundice for several weeks. Laboratory, radiologic and histologic evaluations revealed no other cause of liver injury. He was treated symptomatically and did not receive corticosteroids, eventually recovering completely. The pattern of liver injury was categorized as hepatocellular with a R ratio of 7.0 initially, but serum aminotransferase levels fell promptly and alkaline phosphatase values rose so that the pattern was distinctly cholestatic after the first week. The presence of pruritus and liver histology confirmed the cholestatic nature of the hepatitis.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Acitretin – Generic, Soriatane®

DRUG CLASS

Dermatologic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Acitretin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Acitretin | 55079-83-9 | C21-H26-O3

## CITED REFERENCES

1 Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: the DILIN Prospective Study. Gastroenterology.

## ANNOTATED BIBLIOGRAPHY

References updated: 10 November 2020

Zimmerman HJ. Vitamin A(retinol). Drugs used in dermatotherapy. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 727-9. (Expert review of hepatotoxicity of vitamin A and the retinoids published in 1999; mentions two published reports of acute necrosis due to acitretin).
Liu LU, Schiano TD. Vitamin A (retinol). Hepatotoxicity of herbal medications, vitamins and natural hepatotoxins. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 744-6. (Review of vitamin A and retinoid hepatotoxicity published in 2007).
Sewell MJ, Burkhart C, Morrell D. Dermatological pharmacology. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1271-96. (Textbook of pharmacology and therapeutics).
Peck GL, Olsen TG, Yoder FW, Strauss JS, Downing DT, Pandya M, Butkus D, et al. (1979). Prolonged remissions of cystic and conglobate acne with 13-cis-retinoic acid. N Engl J Med. (Initial report on use of isotretinoin for severe acne mentions that mild and transient ALT elevations occurred in one of the 14 patients treated for 4 months).
Thune P, Mork NJ. (1980). A case of centrolobular toxic necrosis of the liver due to aromatic retinoid--Tigason (Ro-10-9359). Dermatologica. (54 year old woman with ichthyosis developed fatigue 2-3 months after starting etretinate [peak bilirubin 2.6 mg/dL, ALT 1260 U/L, Alk P 350 U/L], biopsy showing centrolobular necrosis, with slow resolution over the next 6 months).
Peck GL, Olsen TG, Butkus D, Pandya M, Arnaud-Battandier J, Gross EG, Windhorst DB, et al. (1982). Isotretinoin versus placebo in the treatment of cystic acne. A randomized double-blind study. J Am Acad Dermatol. (Controlled trial of 4 months of isotretinoin in 33 patients with severe acne showed dramatic therapeutic effect; side effects were dry skin, eyes and nasal membranes and dermatitis; ALT elevations occurred in 3 patients [10%], but levels returned to normal despite continuing and no patient stopped therapy because of side effects).
Glazer SD, Roenigk HH, Yokoo H, Sparberg M. (1982). A study of potential hepatotoxicity of etretinate used in the treatment of psoriasis. J Am Acad Dermatol. (20 patients with psoriasis underwent liver biopsy before and/or up to 6 months after starting etretinate, 20% had ALT elevations, but no worsening of fibrosis or consistent effect on histology).
Olson JA. (1983). Adverse effects of large doses of vitamin A and retinoids. Semin Oncol. (Review of retinoids and vitamin A which do not share same toxicity, but usually have a low therapeutic-toxic index).
Beck HI, Foged EK. (1983). Toxic hepatitis due to combination therapy with methotrexate and etretinate in psoriasis. Dermatologica. (47 year old woman with psoriasis who had been on oral weekly methotrexate for 10 years with normal liver tests, developed fever, jaundice and ascites 4 months after adding 25-75 mg/day etretinate [bilirubin 17 mg/dL, AST 460 U/L, Alk P 1.5 times ULN, prothrombin index 27%], with resolution 2 months after stopping both agents; liver biopsy later showed cirrhosis).
van Voorst Vader PC, Houthoff HJ, Eggink HF, Gips CH. (1984). Etretinate (Tigason) hepatitis in 2 patients. Dermatologica. (2 women with etretinate hepatotoxicity; 70 and 61 year olds with onset of liver tests abnormalities 6 and 3 months after starting etretinate [bilirubin normal, ALT 31 and 476 U/L, Alk P 166 and 147 U/L], resolving within 2-3 months of stopping and recurring within a month of rechallenge or switching to a lower dose [while ALT remaining mildly abnormal]).
Danan G, Pessayre D, Rueff B, Benhamou JP. (1984). Gastroenterol Clin Biol. (3 women, ages 25 to 44 years, developed symptoms of hepatitis 2-10 weeks after starting Plethoryl, a mixture including 50,000 IU of a retinoid marketed in Europe for treatment of obesity [bilirubin 2.6-3.8 mg/dL, ALT 490-576 U/L, Alk P normal], resolving within 4-8 weeks of stopping).
Foged E, Bjerring P, Kragballe K, Sød H, Zachariae H. (1984). Histologic changes in the liver during etretinate treatment. J Am Acad Dermatol. (Among 32 patients treated with etretinate for 6-60 months undergoing liver biopsy, changes included mild fatty change, nuclear variability and minimal fibrosis, but similar changes were found in controls).
Weiss VC, West DP, Ackerman R, Robinson LA. (1984). Hepatotoxic reactions in a patient treated with etretinate. Arch Dermatol. (74 year old woman developed fatigue and fever 1 month after starting etretinate [bilirubin normal, ALT 545 U/L, Alk P 265 U/L, eosinophils 14-24%], rapidly improving upon stopping and recurring within one month of restarting).
Gavish D, Katz M, Gottehrer N, Israeli A, Lijovetzky G, Holubar K. (1985). Cholestatic jaundice, an unusual side effect of etretinate. J Am Acad Dermatol. (58 year old man with psoriasis developed jaundice and pruritus 12 weeks after starting etretinate [bilirubin rising to 23.4 mg/dL, ALT 60 U/L, Alk P 420 U/L], resolving within 4 weeks of stopping; biopsy showed cholestatic hepatitis).
Grimaud JC, Langier R, Costa-Legre MC, Payan MJ. (1985). Presse Med. (62 year old man with psoriasis developed abnormal serum enzyme levels 10 days after restarting etretinate which had been given for 3 months in the past [ALT 420 U/L, Alk P 176 U/L, bilirubin not given], resolving within 2 months of stopping).
Weiss VC, Layden T, Spinowitz A, Buys CM, Nemchausky BA, West DP, Emmons KM. (1985). Chronic active hepatitis associated with etretinate therapy. Br J Dermatol. (39 year old man with psoriasis developed nausea 6 months after starting etretinate [bilirubin normal, ALT 495 U/L, Alk P 141 U/L], with persistence of ALT elevations for 6 months after stopping and biopsy showing "chronic active hepatitis").
Heller EH, Shiffman NJ. (1985). Synthetic retinoids in dermatology. Can Med Assoc J. (Discussion of two synthetic analogues of vitamin A introduced into dermatology: isotretinoin [used in acne] and etretinate [used in psoriasis]; these retinoids are less toxic than vitamin A and not stored in the liver, although they are metabolized there; minor liver test abnormalities may arise during therapy, but rarely required dose modification).
Vahlquist A. (1985). LöL, Nordlinder H, Rollman O, Vahlquist C. Differential hepatotoxicity of two oral retinoids (etretinate and isotretinoin) in a patient with palmoplantar psoriasis. Acta Derm Venereol. (64 year old woman was found to have abnormal liver tests 5 months after starting etretinate [bilirubin 0.7 mg/dL, ALT 950 U/L, Alk P 402 U/L], liver biopsy showing hepatitis without steatosis, resolving with stopping and prednisone therapy, recurring upon rechallenge, but not when isotretinoin was started which was less effective for the psoriasis).
Atttali P, Bernuau J, Fabre M, Degott C, Ink O. (1986). Gastroenterol Clin Biol. (22 year old developed fatigue 2 weeks and jaundice 3 weeks after starting Plethoryl, a combination drug for obesity which includes a retinoid [bilirubin 12.3 mg/dL, ALT 5,500 U/L], progressing to hepatic failure and death one month later).
Jean-Pastor MJ, Jean P, Biour M, Castot A, Chichmanian F, Danan G, Levy VG, et al. (1986). J Toxicol Clin Exp. (Summary of 9 cases of liver injury attributed to use of Plethoryl, 6 of which were considered convincing; all in obese women, ages 24 to 50 years with latency to onset of 2 weeks to 2 years, 3 with jaundice, all resolving after stopping and 3 recurring upon reexposure, injury attributed to a retinol [50,000 IU] in the commercial product).
Marti R, Voiment YM, André M. (1986). Gastroenterol Clin Biol. (36 year old woman developed fever and arthralgias 3 months after starting Plethoryl, a drug combination for obesity which includes a retinoid [bilirubin 4.0 mg/dL, ALT 708 U/L, Alk P 137 U/L], resolving rapidly upon stopping and recurring within 5 days of restarting).
Camuto P, Shupack J, Orbuch P, Tobias H, Sidhu G, Feiner H. (1987). Long-term effects of etretinate on the liver in psoriasis. Am J Surg Pathol. (18 patients treated with etretinate for psoriasis for at least 5 years underwent liver biopsy; 2 had persistent liver test elevations, one had Alk P >500 U/L with a "normal" liver biopsy, one had ALT of 125 U/L with chronic hepatitis and fibrosis on biopsy [no HCV testing available], a third had normal tests but had cirrhosis on biopsy; many biopsies showed fatty change and occasional stellate cell hypertrophy).
Yob EH, Pochi PE. (1987). Side effects and long-term toxicity of synthetic retinoids. Arch Dermatol. (Retinoids are modifications of vitamin A molecule and are not stored in the liver; hepatotoxicity of retinoids is different from that of vitamin A, usually arising within first 1-2 months and having features of hypersensitivity).
Khouri MR, Saul SH, Dlugoz AA, Soloway RD. (1987). Hepatocanalicular injury associated with vitamin A derivative etretinate. Dig Dis Sci. (73 year old man with psoriasis developed fever 3-4 weeks after starting etretinate [bilirubin 0.8 mg/dL, ALT 126 U/L, Alk P 383 U/L, eosinophils 1368/μL], jaundice arising with continuation of drug for 5 days [peak bilirubin 2.5 mg/dL], resolving within 2 weeks of stopping).
Kingston TP, Matt LH, Lowe NJ. (1987). Etretin therapy for severe psoriasis. Arch Dermatol. (Open label study of etretin [acitretin] in 21 patients with psoriasis, 3 required dose modification for liver test elevations, but few details given).
Larrey D, Fréaux E, Babany G, Berson A, Amée-Manesme O, Degott C, Bettan L, et al. (1988). Gastroenterol Clin Biol. (Seven cases of liver injury in women taking Plethoryl [a retinoid containing combination used to treat obesity], arising after 3-16 weeks of therapy [bilirubin 3.3-26.3 mg/dL, ALT 21-61 times ULN, Alk P 0.9-1.8 times ULN], resolving within 2-3 months of stopping).
Prudent A, Marchetti B, Philibert P, Lacroix G. (1988). Legré. Ann Gastroenterol Hepatol (Paris). (48 year old woman developed nausea, fatigue, and arthralgias 6 month after starting Plethoryl for weight loss [bilirubin 2.2 mg/dL, ALT 588 U/L, Alk P 448 U/L], which resolved on stopping and recurred within a week of restarting on two occasions).
David M, Hodak E, Lowe NJ. (1988). Adverse effects of retinoids. Med Toxicol Adverse Drug Exp. (Review of pharmacology, clinical effectiveness and low dose, long term toxicities of the retinoids; states that therapy usually has little effect on ALT or bilirubin levels).
Roenigk HH. (1988). Liver toxicity of retinoid therapy. J Am Acad Dermatol. (Review of hepatotoxicity of vitamin A and the retinoids).
Thirumoorthy T, Shupack JL. (1988). Adverse hepatic reactions associated with etretinate in patients with psoriasis--analysis of 22 cases. Ann Acad Med Singapore. (Among 533 patients with psoriasis treated with etretinate, there were 22 reports of hepatic adverse events [4%]; 6 were considered probably related, 7 possibly, 6 unlikely and 3 unclassifiable; 2 patients developed fever, malaise and rash 4-5 weeks after starting etretinate with rapid rise in ALT and rapid resolution on stopping; others had serum enzyme elevations without symptoms or jaundice).
Zachariae H. (1988). Dangers of methotrexate/etretinate combination therapy. Lancet. (2 of 10 patients on the combination of etretinate and methotrexate developed severe liver injury, including a 47 year old man who developed jaundice 1 month after adding etretinate to chronic methotrexate therapy [bilirubin 17.1 mg/dL, AST 305 U/L, Alk P 742 U/L], which resolved within 2 months of stopping both).
Causse X, Paliard P. (1989). Gastroenterol Clin Biol. (32 year old woman developed jaundice 4-6 weeks after starting Plethoryl for obesity [bilirubin 12.2 mg/dL, ALT 1690 U/L], but continued drug for 2 months and developed ANA 1:1024, responding to course of corticosteroid therapy; ultimately liver tests were normal and ANA fell to 1:40; Plethoryl [a drug combination that included a synthetic retinoid] was withdrawn from market in France in 1988).
Gupta AK, Goldfarb MT, Ellis CN, Voorhees JJ. (1989). Side-effect profile of acitretin therapy in psoriasis. J Am Acad Dermatol. (Controlled trial of 4 different doses of acitretin in 38 patients with psoriasis, followed by open label long term use, 15% had ALT or AST elevations during therapy, rising above 100 U/L in two patients, without jaundice, and resolving rapidly on stopping).
Maroy B, Moullot P, Constantin JM. (1989). Presse Med. (4 cases of adverse events due to use of Plethoryl, including 2 instances of acute hepatocellular injury, 1 of cirrhosis and 1 of arthritis which improved on stopping Plethoryl).
Roenigk HH. (1989). Liver toxicity of retinoid therapy. Pharmacol Ther. (Review of toxicity of retinoids including description of liver biopsy results described by Glazer [1982]).
Kragballe K, Jansen CT, Geiger JM, Bjerke JR, Falk ES, Gip L, Hjorth N, et al. (1989). A double-blind comparison of acitretin and etretinate in the treatment of severe psoriasis. Results of a Nordic multicentre study. Acta Derm Venereol. (Controlled trial of acitretin [n=127] vs etretinate [n=41] in psoriasis found similar efficacy; AST elevations occurred in 12% vs 11% and one patient on acitretin for 12 weeks developed biopsy proven "toxic hepatitis" which resolved on stopping).
Olsen EA, Weed WW, Meyer CJ, Cobo LM. (1989). A double-blind, placebo-controlled trial of acitretin for the treatment of psoriasis. J Am Acad Dermatol. (Controlled trial of acitretin in 15 patients with psoriasis, including a 28 year old man who developed fatigue and elevated liver tests [bilirubin 0.5 mg/dL, ALT 396 U/L, Alk P 140 U/L], which resolved within 2 months of stopping).
van Ditzhuijsen TJ, van Haelst UJ, van Dooren-Greebe RJ, van de Kerkhof PC, Yap SH. (1990). Severe hepatotoxic reaction with progression to cirrhosis after use of a novel retinoid (acitretin). J Hepatol. (50 year old woman with psoriasis developed elevated liver tests 4-5 months after starting acitretin [bilirubin normal, ALT 790 U/L, Alk P 166 U/L] and worsened for 2 months after stopping [bilirubin rising to 3.8 mg/dL]; liver biopsy showed severe hepatitis with bridging necrosis and, on follow up, an inactive cirrhosis despite all liver tests returning to normal).
Fallon MB, Boyer JL. (1990). Hepatic toxicity of vitamin A and synthetic retinoids. J Gastroenterol Hepatol. (Review of liver injury due to hypervitaminosis A and retinoids identified 18 reports of vitamin A hepatotoxicity in the English literature, patient ages 6 to 63 years, presenting with rash, fatigue, hepatomegaly and hepatic synthetic dysfunction, biopsy showing fat in stellate cells and fibrosis; little evidence that isotretinoin causes liver injury other than mild rapidly reversible ALT elevations; etretinate causes ALT elevations in ~20% of patients and case reports of clinically apparent injury have been published, but vary in clinical patterns).
Marhold I, Duschet P, Schwarz T, Gschnait F. (1991). Hautarzt. (29 year old woman with psoriasis responded to etretinate but developed rising Alk P levels [172 to 1736 U/L] without jaundice and only mild ALT increases [38 to 178 U/L] 24 days after starting therapy, which improved on stopping and she later tolerated isotretinoin without recurrence [Alk P 118 U/L, ALT 14 U/L]).
Dubois A, Balducchi JP, Barbuat C, Fabre J, Flaisler F, Joujoux JM, Pignodel C, et al. (1991). Rev Med Interne. (Two patients presented with ascites and biopsy showing stellate cell hypertrophy one having taken methoxypsoralen [for tanning] and one Plethoryl [for weight loss] for several years, improving on stopping).
Navascués CA, Suáz A, Riestra S, Rodrigo L. (1991). Med Clin (Barc). (81 year old man treated with etretinate for psoriasis for 7 months developed jaundice [bilirubin 2.4 mg/dL, ALT 804 U/L, Alk P 3 times ULN, protime 17 seconds]).
Green C, Lakshmipathi T. (1991). A case of hepatitis related to etretinate therapy and hepatitis B vaccine. Dermatologica. (41 year old man with psoriasis had mild fluctuations in serum AST during etretinate therapy ultimately [at 9 months] rising to 361 U/L, without jaundice or symptoms and resolving rapidly with discontinuation).
Murray HE, Anhalt AW, Lessard R, Schacter RK, Ross JB, Stewart WD, Geiger JM. (1991). A 12-month treatment of severe psoriasis with acitretin: results of a Canadian open multicenter study. J Am Acad Dermatol. (Open label study of 12 month course of acitretin in 63 patients with psoriasis, ALT elevations occurred in ~10% of patients, one requiring discontinuation [ALT 3 times ULN at 5 months, resolving within two months of stopping]).
Vahlquist A. (1992). Long-term safety of retinoid therapy. J Am Acad Dermatol. (Patients have been treated with retinoids for up to 15 years, generally without toxicity; retinoids do not accumulate in the liver and do not cause accumulation of fat droplets in stellate cells as occurs with hypervitaminosis A; two types of hepatotoxicity, one idiosyncratic acute hepatitis typically occurring with aromatic retinoids and one a long term low grade injury that can lead to cirrhosis, perhaps aggravated by alcohol that the author claims can occur with all retinoids).
Mørk NJ. (1992). Kolbenstvedt, Austad J. Efficacy and skeletal side effects of two years' acitretin treatment. Acta Derm Venereol. (One of 51 patients with psoriasis treated with acitretin for up to 2 years developed "toxic hepatitis" which arose after 5 months of treatment and resolved 20 weeks after stopping; few details given).
Pilkington T, Brodgen RN. (1992). Acitretin: a review of its pharmacology and therapeutic use. Drugs. (Extensive review of the pharmacology, clinical efficacy, and toxicity of acitretin; vitamin A-like side effects are common such as dry skin, lips, eyes and nose, skin desquamation, alopecia, fatigue and pruritus; ALT elevations occur in 16%, but are usually asymptomatic, although cases requiring drug withdrawal have been reported).
Coschieri M, Philippon A, Quinsat D, Dor JF, Chichmanian RM. (1993). Acute hepatitis involvement during ingestion of acitretin. Gastroenterol Clin Biol. (80 year old man developed nausea and rash one week after starting acitretin [bilirubin normal, ALT 21 times ULN, Alk P normal], resolving within a month of stopping).
Sanchez MR, Ross B, Rotterdam H, Salik J, Brodie R, Freedberg IM. (1993). Retinoid hepatitis. J Am Acad Dermatol. (65 year old woman developed elevated ALT levels 2 months after starting etretinate [bilirubin 2.9 rising to 6.7 mg/dL, ALT 820 U/L, Alk P 250 U/L], worsening for 2 months after stopping and then resolving).
Kano Y, Fukuda M, Shiohara T, Nagashima M. (1994). Cholestatic hepatitis occurring shortly after etretinate therapy. J Am Acad Dermatol. (65 year old man with psoriasis developed fever and jaundice within 7 days of starting etretinate, resolving within 2 weeks of stopping; few details given).
Shibata K, Shimamoto Y, Ishibashi S, Tominaga H, Suga K, Yamaguchi M. (1994). Life-threatening hepatic toxicity caused by all-trans-retinoic acid in a patient with acute promyelocytic leukaemia. Clin Lab Haematol. (39 year old man with acute promyelocytic leukemia developed jaundice one month after starting all-trans-retinoic acid with peak bilirubin ~10 mg/dL, resolving in 18 days after stopping and patient achieving remission despite early discontinuation).
Krüger-Krasagakes S, Grabbe J, Czarnetzki BM. (1995). Possible aggravation of hepatitis A by acitretin. Acta Derm Venereol. (49 year old man developed fatigue 1 month and fever and jaundice 2 months after starting acitretin [bilirubin ~12 mg/dL, ALT ~2500 U/L, Alk P normal, protime 50%], but was also IgM anti-HAV positive; authors hypothesize that acitretin like vitamin A may worsen the course of acute viral hepatitis).
Stern RS, Fitzgerald E, Ellis CN, Lowe N, Goldfarb MT, Baughman RD. (1995). The safety of etretinate as long-term therapy for psoriasis: results of the etretinate follow-up study. J Am Acad Dermatol. (Analysis of prospective survey of 956 patients with psoriasis treated with etretinate for up to 5 years; 66 patients reported hepatic problems during study including 13 with hepatitis and 13 with cirrhosis [5 with both], but relationship to therapy could not be assessed).
Katz HI, Waalen J, Leach EE. (1999). Acitretin in psoriasis: an overview of adverse effects. J Am Acad Dermatol. (Review of side effects of acitretin based upon data from 1877 patients reported "overt chemical hepatitis" in 0.26%; among 128 patients undergoing routine pre- and post-treatment liver biopsies, 83% were improved or unchanged; authors recommend routine monitoring of liver tests every 1-2 weeks "until stable, and thereafter at intervals as clinically indicated").
Roenigk HH, Callen JP, Guzzo CA, Katz HI, Lowe N, Madison K, Nigra T, et al. (1999). Effects of acitretin on the liver. J Am Acad Dermatol. (Among 128 patients treated with acitretin, 83 underwent liver biopsy before and 2 years after starting therapy; 30% had ALT elevations, liver histology did not change on average; one patient developed fibrosis, but had no serum enzyme worsening).
Perea G, Salar A, Alté A, Brunet S, Sierra J. (2000). Acute hepatomegaly with severe liver toxicity due to all-trans-retinoic acid. Haematologica. (40 year old man with promyelocytic leukemia developed jaundice 21 days after starting all-trans-retinoic acid and idarubicin [direct bilirubin 2.3 mg/dL, ALT normal, Alk P 370 U/L], biopsy showing intrahepatic cholestasis and resolving within 2 weeks of stopping).
Mawson AR, Steele TA. (2001). Possible role of retinoids in hepatitis B virus-associated liver damage. Exp Biol Med (Maywood). (Review and hypothesis regarding interactions of vitamin A, retinoids and hepatitis B virus infection).
Kreiss C, Amin S, Nalesnik MA, Chopra K, Shakil AO. (2002). Severe cholestatic hepatitis in a patient taking acitretin. Am J Gastroenterol. (51 year old man with psoriasis developed jaundice 3 months after starting acitretin [bilirubin ~12 rising to 70 mg/dL, initial ALT ~4500 U/L, Alk P ~550 U/L] and had a prolonged relapsing course despite prednisone therapy; liver biopsy showed intrahepatic cholestasis and fibrosis).
Van Zander J, Orlow SJ. (2005). Efficacy and safety of oral retinoids in psoriasis. Expert Opin Drug Saf. (Review of acitretin and other retinoids as therapy of psoriasis; side effects include ALT elevations in one third of treated patients, but clinically apparent liver injury is rare).
Pang ML, Murase JE, Koo J. (2008). An updated review of acitretin-a systemic retinoid for the treatment of psoriasis. Expert Opin Drug Metab Toxicol. (Side effects of acitretin are somewhat dose related, liver enzyme elevations in 25-30% of patients, but usually with high dose therapy, occurring 2-8 weeks after starting therapy and transient or responding to dose modification).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, one was attributed to acitretin: Case 1 for acitretin).
Leithead JA, Simpson KJ, MacGilchrist AJ. (2009). Fulminant hepatic failure following overdose of the vitamin A metabolite acitretin. Eur J Gastroenterol Hepatol. (42 year old woman took an 600 mg overdose of acitretin and presented 2 days later with acute liver failure [bilirubin 5.7 mg/dL, ALT 10,226 U/L, Alk P 153 U/L, protime 51 seconds and renal dysfunction]; acitretin levels were undetectable and she recovered spontaneously).
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. (2010). Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol. (Among 313 cases of drug induced liver injury seen between 1997 and 2008 at a large hospital in Bangalore, India, no cases were attributed to vitamin A or retinoids).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to vitamin A or a retinoid).
Mas Morey P, Nigorra Caro M, Cladera Serra A, Nicolás Picó J. (2011). Possible fulminant toxicity by all-trans-retinoic acid in a patient with acute promyelocytic leukemia. Farm Hosp. (33 year old woman with promyelocytic leukemia treated with all-trans-retinoic acid developed acute liver failure within 3 weeks of starting [bilirubin 1.1 rising to 17.4 mg/dL], with progressive pulmonary and renal failure and death 25 days after starting).
Stickel F, Kessebohm K, Weimann R, Seitz HK. (2011). Review of liver injury associated with dietary supplements. Liver Int. (Review of the hepatotoxicity of herbals and nutritional supplements including vitamin A, toxic levels being above 50,000 IU daily, but toxic dose is lower in persons with risk factors such as underlying liver disease).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, three of which were attributed to isotretinoin [ranking 6th in frequency] all of which were anicteric and only one symptomatic).
Lérisson M, Ripault MP, Pageaux GP, Guillot B, Larrey D. (2014). Hepatitis after retinoid percutaneous administration. Clin Res Hepatol Gastroenterol. (55 year old woman with Darier disease developed anicteric hepatitis 10 months after starting acitretin [bilirubin 0.4 mg/dL, 107 U/L, Alk P 319 U/L] which resolved on stopping, but reappeared 8 months after starting topical acitretin [bilirubin 0.7 mg/dL, ALT 403 U/L, Alk P 203 U/L], resolving 6 months after stopping).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, two of which were attributed to retinoids).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: the DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 3 cases were attributed to acitretin, but none to other retinoids or vitamin A).
Homma Y, Otani N, Ishimatsu S. (2015). A case report of acute vitamin A intoxication due to ocean perch liver ingestion. J Emerg Med. (27 year old man developed flushing, headache, nausea and joint pains one day after eating 800 g of ocean perch liver, with normal liver enzymes, but high retinol levels and subsequent facial desquamation).
Mengual-Moreno E, Lizarzábal-García M, Ruiz-Soler M, Silva-Suarez N, Andrade-Bellido R, Lucena-González M, Bessone F, et al. (2015). Invest Clin. (During a one year period, 13 cases of drug induced liver injury were seen at a single hospital in Venezuela, the implicated agents being acetaminophen [3], ibuprofen [3], isoniazid [2], Herbalife products [2: one fatal], and 1 each of isotretinoin, amoxicillin/clavulanate and methotrexate).
Sauder MB, Cheung L, Beecker J. (2015). Acitretin-induced hepatitis: when to monitor cholestatic enzymes. J Cutan Med Surg. (69 year old woman with bullous lichen sclerosus developed serum enzyme elevations without symptoms or jaundice within 2 weeks of starting acitretin and prednisone [bilirubin normal, peak ALT 328 U/L, Alk P 295 U/L], improving rapidly upon stopping acitretin, later tolerating methotrexate).
Borghi A, Corazza M, Bertoldi AM, Caroppo F, Virgili A. (2015). Low-dose acitretin in treatment of plaque-type psoriasis: descriptive study of efficacy and safety. Acta Derm Venereol. (Among 46 patients with moderate-to-severe plaque psoriasis treated with acitretin, the response rate was 67% and adverse events occurred in 39%, which was mostly alopecia, dry eyes, cheilitis, fatigue, hyperlipidemia and gastrointestinal upset, and only one person [2%] was listed as having elevated aminotransferase levels).
(2019). Drugs for psoriasis. Med Lett Drugs Ther. (Concise review of the drugs approved for use in psoriasis including their mechanism of action, clinical efficacy, safety and costs, mentions that acitretin has significant mucocutaneous toxicity with cheilitis, hair loss, dry skin and desquamation and that about one third of patients have ALT elevations during therapy that are usually mild and transient but can evolve into clinically significant liver injury and can lead to cirrhosis).
Nikolaou V, Patsatsi A, Sidiropoulou P, Chlouverakis G, Kavvalou E, Koletsa T, Economidi A, et al. (2020). Monotherapy and combination therapy with acitretin for mycosis fungoides: results of a retrospective, multicentre study. J Eur Acad Dermatol Venereol. (Among 128 patients with mycosis fungoides treated with acitretin starting with low doses, the overall response rate was 77% and the adverse event rate 48%, most commonly dyslipidemia [24%], xerosis [19%] and hair loss [8%]; no mention of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Acitretin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Acitretin/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Acitretin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Acitretin)